# Midazolam

## OVERVIEW

### Introduction

Midazolam is an intravenously administered benzodiazepine used as an anesthetic for conscious sedation for minor procedures and as an adjunct for general anesthesia. Midazolam has not been associated with serum aminotransferase elevations during therapy and has not been linked to cases of clinically apparent liver injury.

### Background

Midazolam (mi daz' oh lam) is a benzodiazepine with particularly potent sedative activity. The sedative activity of the benzodiazepines is mediated by their ability to enhance gamma-aminobutyric acid (GABA) mediated inhibition of synaptic transmission through binding to the GABA A receptor. The use of midazolam has been largely as an intravenous anesthetic agent. Midazolam is used for conscious sedation for short-term, outpatient procedures such as upper and lower endoscopy, bronchoscopy, liver biopsy and cardiac catheterization. It is also used for induction of general anesthesia and for preoperative sedation. Midazolam is associated with anterograde amnesia which is often convenient for uncomfortable, minimally invasive procedures. Midazolam is available generically (and formerly under the brand name Versed) in parenteral forms for injection [1 mg/mL in 1-, 2-, 5-, and 10-mL vials], in disposal syringes and as an oral solution for pediatric use perioperatively. The typical dose for conscious sedation in adults is 1 to 4 mg intravenously over 2 to 5 minutes. Common side effects of the use of intravenous midazolam include nausea, hypotension, confusion, acute agitation, and respiratory depression. Acute overdose of midazolam can cause respiratory arrest and death. Midazolam has a boxed warning in its product label about the risks of severe respiratory depression with its use, a warning against combined use with opiates, and need to individualize the dose, to monitor respiratory and cardiac status, and have resuscitative drugs and equipment available.

### Hepatotoxicity

Midazolam, like other benzodiazepines, is rarely associated with serum ALT or alkaline phosphatase elevations. Clinically apparent liver injury from midazolam has not been reported and must be extremely rare, if it occurs at all. Isolated single cases of clinically apparent liver injury have been reported with other benzodiazepines including alprazolam, chlordiazepoxide, clonazepam, diazepam, flurazepam, lorazepam, and triazolam. The clinical pattern of acute liver injury from benzodiazepines is typically cholestatic, but hepatocellular patterns of injury have been reported with clorazepate and clotiazepam. The injury is usually mild to moderate in severity with a time to onset of 1 to 6 months and rapid recovery once the benzodiazepine is stopped. Fever and rash are uncommon as is autoantibody formation.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

Midazolam is extensively metabolized by the liver to inactive metabolites which are excreted in the urine. The liver injury from benzodiazepines is probably due to a rarely produced intermediate metabolite. The absence of liver injury is perhaps due to the short duration of therapy and low doses used.

### Outcome and Management

In the isolated case reports of hepatic injury due to benzodiazepines recovery was rapid and complete after stopping the medication, without evidence of residual or chronic injury. No cases of acute hepatitis, liver failure, or chronic liver injury due to midazolam have been described. There is no information about cross reactivity with other benzodiazepines, but some degree of cross sensitivity may occur.

Drug Class: Sedatives and Hypnotics, Benzodiazepines, Antianxiety Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Midazolam – Generic, Versed® (Trade name discontinued)

DRUG CLASS

Benzodiazepines

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=midazolam)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Midazolam | 59467-70-8 | C18-H13-Cl-F-N3

## ANNOTATED BIBLIOGRAPHY

References updated: 22 June 2023

Zimmerman HJ. Benzodiazepines. Psychotropic and anticonvulsant agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 491-3. (Expert review of benzodiazepines and liver injury published in 1999; mentions rare instances of cholestatic hepatitis have been reported due to alprazolam, chlordiazepoxide, diazepam, flurazepam, and triazolam, and hepatocellular injury with clorazepate and clotiazepam, but no reports of hepatic injury with lorazepam, oxazepam, or temazepam).
Larrey D, Ripault MP. Benzodiazepines. Hepatotoxicity of psychotropic drugs and drugs of abuse. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 455. (Review of benzodiazepine induced liver injury mentions that increases in liver enzymes during therapy are rare and significant hepatotoxicity uncommon; only a few cases [usually cholestatic] have been reported with alprazolam, chlordiazepoxide, diazepam, flurazepam, and triazolam).
Mihic SJ, Mayfield J, Harris RA. Hypnotics and sedatives. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 339-53. (Textbook of pharmacology and therapeutics).
Wallace SJ. (1996). A comparative review of the adverse effects of anticonvulsants in children with epilepsy. Drug Saf. (Systematic review; ALT elevations occur in 4% of children on phenytoin, 6% on valproate, 1% on carbamazepine; but “no child taking… benzodiazepines had raised liver enzyme levels”).
Lewis JH, Zimmerman HJ. (1999). Drug- and chemical-induced cholestasis. Clin Liver Dis. (Review of drug induced cholestatic syndromes, listing many causes including chlordiazepoxide and flurazepam; “benzodiazepines may cause cholestatic injury, although this is rare”).
Sabaté M, Ibáñez L, Pérez E, Vidal X, Buti M, Xiol X, Mas A, et al. (2007). Risk of acute liver injury associated with the use of drugs: a multicentre population survey. Aliment Pharmacol Ther. (Among 126 cases of drug induced liver injury seen in Spain between 1993-2000, 20 were attributed to benzodiazepines including 5 for clorazepate, 5 alprazolam, 6 lorazepam, and 4 diazepam, but compared to controls, relative risk of injury was increased only for clorazepate [8.3: estimated frequency 3.4 per 100,000 person-year exposures]).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, none attributed to a benzodiazepine).
Björnsson E. (2008). Hepatotoxicity associated with antiepileptic drugs. Acta Neurol Scand. (Review of hepatotoxicity of all anticonvulsants focusing upon phenytoin, valproate, carbamazepine; “furthermore, hepatoxicity has not been convincingly shown to be associated with the use of benzodiazepines”).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology. (In a population-based study of drug induced liver injury from Iceland, 96 cases were identified over a 2-year period, but none were attributed to midazolam or any other benzodiazepine, despite the fact millions of prescriptions for them are filled yearly).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol. (Systematic review of literature on drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, none of which were attributed to midazolam or any other benzodiazepine).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, no cases were attributed to midazolam or any other benzodiazepine).
Rex DK, Bhandari R, Desta T, DeMicco MP, Schaeffer C, Etzkorn K, Barish CF, et al. (2018). A phase III study evaluating the efficacy and safety of remimazolam (CNS 7056) compared with placebo and midazolam in patients undergoing colonoscopy. Gastrointest Endosc. (Among 461 adults undergoing colonoscopy who received remimazolam, midazolam, or placebo as a procedural sedative after a single dose of fentanyl, adequate sedation was achieved more frequently with remimazolam and onset after starting and recovery of full alertness after stopping was more rapid with remimazolam, with similar rates of adverse events and no serious adverse event).
Pastis NJ, Yarmus LB, Schippers F, Ostroff R, Chen A, Akulian J, Wahidi M, et al. (2019). PAION Investigators. Safety and efficacy of remimazolam compared with placebo and midazolam for moderate sedation during bronchoscopy. Chest. (Among 446 patients undergoing bronchoscopy who received procedural sedation with remimazolam, midazolam or placebo, the onset of adequate sedation was faster with remimazolam than midazolam and time to being fully alert was more rapid after stopping while total and severe adverse event rates were similar in the three groups and success rates in completing the procedure were similar; no mention of ALT elevations or hepatotoxicity).

## OTHER REFERENCE LINKS

1 Recent References on Midazolam: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Midazolam/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Midazolam: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Midazolam)